# Carboplatin

## OVERVIEW

### Introduction

Carboplatin is an intravenously administered platinum coordination complex and alkylating agent which is used as a chemotherapeutic agent for the treatment of various cancers, mainly ovarian, head and neck and lung cancers. Carboplatin therapy is associated with a low rate of transient serum aminotransferase elevations and with rare instances of clinically apparent liver injury.

### Background

Carboplatin (kar" boe pla' tin) is a cisplatin analog with a carboxy-cyclobutane moiety instead of the chloride atoms which makes it more stable and perhaps less toxic than cisplatin. Carboplatin and cisplatin act as alkylating agents causing cross linking between and within DNA strands, leading to inhibition of DNA, RNA and protein synthesis and the triggering of programmed cell death, mostly in rapidly dividing cells. Carboplatin was approved for use in cancer chemotherapy in the United States in 1989. It is currently indicated for advanced ovarian carcinoma, but is also used in other solid tumors including lung and head and neck cancer. Carboplatin is available in a powder or aqueous solution for injection in 50, 150 and 450 mg amounts generically and under the brand name Paraplatin. The platinum coordinating complexes have similar toxicities, including nausea and vomiting, diarrhea, bone marrow suppression, as well as neuro-, oto- and nephrotoxicity. They are also mutagenic, teratogenic and carcinogenic. Carboplatin is somewhat better tolerated than cisplatin.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are found in up to one-third of patients taking carboplatin. However, clinically apparent acute liver injury from carboplatin is extremely rare and the characteristics of such injury have not been well defined. In addition, carboplatin has been used in combination with other alkylating agents in high doses in conditioning regimens in preparation of hematopoietic cell transplantation which may be associated with instances of sinusoidal obstruction syndrome, which can be severe and lead to acute liver failure. Onset of sinusoidal obstruction syndrome is generally within 10 to 20 days of transplantation and presents with right upper quadrant pain, hepatic tenderness, weight gain, edema and ascites, followed by jaundice. The role of carboplatin in causing these cases of sinusoidal obstruction syndrome has not been well defined.

Carboplatin is usually given in combination with other antineoplastic agents and adverse events that occur with these combinations cannot always be attributed to carboplatin. In this regard, individual case reports of reactivation of hepatitis B, acute hepatic necrosis, sinusoidal obstruction syndrome and severe hyperammonemic coma (without liver injury) have been described after chemotherapeutic regimens that include carboplatin and other platinum coordination complexes such as cisplatin and oxaliplatin. In most of these instances, it is difficult to assign a specific role for carboplatin in causing the injury.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of idiosyncratic hepatotoxicity from carboplatin is not known, but is possibly due to an intermediate in its metabolism. Sinusoidal obstruction syndrome is probably due to direct toxic effects of the myeloablative regimen on sinusoidal lining cells.

### Outcome and Management

The severity of liver injury from carboplatin ranges from mild, reversible enzyme elevation to sinusoidal obstruction syndrome with acute liver failure and death. Liver injury from carboplatin is extremely rare. There is likely to be cross sensitivity to liver toxicities of the various platinum coordination complexes and rechallenge after clinically apparent liver injury should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents

Other Drugs in the Subclass, Platinum Coordination Complexes: Cisplatin, Oxaliplatin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carboplatin – Generic, Paraplatin®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Carboplatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Carboplatin | 41575-94-4 | C6-H12-N2-O4-Pt

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Abbreviations: BMI, body mass index; CT, computerized tomography; NRH, nodular regenerative hyperplasia; SOS, sinusoidal obstruction syndrome; HVPG, hepatic venous pressure gradient; SAMe, S-adenosylmethionine.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that cisplatin had been reported to cause dose related serum enzyme elevations and has been linked to steatosis and necrosis, whereas carboplatin has been linked to rare instances of cholestatic and hepatocellular injury).
DeLeve LD. Liver sinusoidal endothelial cells and liver injury. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 139-43. (Review of liver injury to sinusoidal endothelial cells caused by medications mentions that oxaliplatin as capable of causing sinusoidal dilatation, peliosis hepatis, nodular regenerative hyperplasia and sinusoidal obstruction syndrome).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-201. (Textbook of pharmacology and therapeutics).
Canetta R, Franks C, Smaldone L, Bragman K, Rozencweig M. (1987). Clinical status of carboplatin. Oncology (Williston Park). (Summary of clinical studies of carboplatin, a cisplatin derivative; carboplatin and cisplatin have similar efficacy against ovarian, cervical and small cell lung cancer, but carboplatin is better tolerated; ALT elevations in 16% of patients, bilirubin in 4%, no mention of clinically apparent hepatotoxicity).
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. (1987). Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, SOS developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population).
Canetta R, Bragman K, Smaldone L, Rozencweig M. (1988). Carboplatin: current status and future prospects. Cancer Treat Rev. (Summary of results of prelicensure trials of carboplatin; no mention of ALT elevations or hepatotoxicity).
Hruban RH, Sternberg SS, Meyers P, Fleisher M, Menendez-Botet C, Boitnott JK. (1991). Fatal thrombocytopenia and liver failure associated with carboplatin therapy. Cancer Invest. (18 year old man with acute lymphocyte leukemia and cirrhosis developed severe thrombocytopenia within 6 days of starting carboplatin [platelet count 15,000/µL, bilirubin 5.6 mg/dL, AST 4690 U/L, Alk P 150 U/L] and death from multiorgan failure 10 days later; autopsy showed cirrhosis and marked centrolobular necrosis).
Tran A, Housset C, Boboc B, Tourani J-M, Carnot F, Berthelot P. (1991). Etoposide (VP 16-213) induced hepatitis: report of three cases following standard dose treatments. J Hepatol. (3 patients, ages 52 to 73 years, developed jaundice 1-5 months after starting etoposide with several other cyclic antineoplastic agents including cisplatin and cyclophosphamide in two [bilirubin 4.2-13.0 mg/dL, ALT 790-2270 U/L, Alk P 181-280 U/L], resolving in 4-10 weeks and no recurrence on a similar regimen without etoposide in one patient).
Bishop JF. (1992). Current experience with high-dose carboplatin therapy. Semin Oncol. (Dose limiting toxicities of high dose carboplatin followed by bone marrow transplantation were reversible cholestatic hepatitis, renal dysfunction and ototoxicity).
Ayash LJ, Elias A, Wheeler C, Reich E, Schwartz G, Mazanet R, Tepler I, et al. (1994). Double dose-intensive chemotherapy with autologous marrow and peripheral-blood progenitor-cell support for metastatic breast cancer: a feasibility study. J Clin Oncol. (Among 29 men with advanced testicular cancer receiving carboplatin and etoposide, 6 [21%] developed "elevation of liver function tests" but no mention of veno-occlusive disease).
Hartmann JT, Lipp H-P. (2003). Toxicity of platinum compounds. Expert Opin Pharmacother. (Review of pharmacology, mechanism of action, adverse effects and tolerance of platinum containing alkylating agents; "Mild reversible increases in liver function tests can occur in patients who have received platinum compounds. However, the platinum compounds are generally not classified as hepatotoxic drugs").
McDonald GB. (2010). Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents).
Laemmle A, Hahn D, Hu L, Rüfenacht V, Gautschi M, Leibundgut K, Nuoffer JM, et al. (2015). Fatal hyperammonemia and carbamoyl phosphate synthetase 1 (CPS1) deficiency following high-dose chemotherapy and autologous hematopoietic stem cell transplantation. Mol Genet Metab. (2 year old boy with neuroblastoma developed severe, refractory hyperammonemia with normal liver tests and liver histology 7 days after hematopoietic cell transplantation and myeloablative therapy with melphalan etoposide and carboplatin, liver tissue revealing virtually no CPS1 activity or protein despite relatively normal mRNA levels and no mutations in the cDNA of the CPS1 gene; in vitro assays demonstrating post-transcription inhibition of CPS1 by the combination of carboplatin and etoposide).
Tareen SA, Rodriguez B, Bolos D. (2020). Retrospective analysis of HER2+ breast cancer outcomes at a county hospital: do published outcomes hold up in the real world?. Cureus. (Among 24 patients with HER2+ breast cancer treated in community practice with a standard regimen of docetaxel, carboplatin, trastuzumab and pertuzumab, clinical response rates were similar to those reported from large registration trials of this regimen [50% vs 52%], but side effects were more common including liver test abnormalities [38% vs 4%] perhaps due to the larger proportion of Hispanic minorities in the treated population [57%]).

## OTHER REFERENCE LINKS

1 Recent References on Carboplatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Carboplatin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Carboplatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carboplatin)